# Linerixibat

## OVERVIEW

### Introduction

Linerixibat is an orally available inhibitor of the ileal bile salt transporter which is used to treat severe pruritus in patients with primary biliary cholangitis. Linerixibat therapy is associated with transient serum enzyme fluctuations particularly with long term therapy but has not been linked to instances of clinically apparent liver injury with jaundice, although experience with its use has been limited.

### Background

Linerixibat (lin e rix' i bat) is a small molecule inhibitor of the ileal bile acid transporter that is used to treat moderate to severe pruritus in patients with primary biliary cholangitis (PBC). The ileal bile acid transporter is responsible for the uptake of bile salts from the terminal ileum, an essential step in the entero-hepatic circulation of bile acids. Interruption of this enterohepatic circulation results in a decrease in serum bile acid levels and decline in the whole-body bile acid pool, both of which are increased in patients with cholestatic liver disease and are associated with the symptom of pruritus. PBC is a chronic liver disease marked by injury and progressive loss of intralobular bile ducts that results in chronic cholestasis and hepatitis fibrosis that can lead to cirrhosis and end-stage liver disease. Pruritus is a common symptom in patients with PBC and may interfere with sleep and worsen quality of life. In randomized placebo controlled clinical trials in adults with PBC, linerixibat resulted in improvements in serum bile acid levels, symptoms of pruritus, sleep quality, and general well-being. Linerixibat was approved as therapy of moderate to severe pruritus in patients with PBC in 2026. It continues to be evaluated for its long-term efficacy and safety in PBC and in other cholestatic liver diseases. It is contraindicated in patients with decompensated cirrhosis. Linerixibat is administered orally, acts locally on the ileal bile acid transporter, and has little systemic absorption. It is available in tablets of 40 mg under the trade name Lynavoy. The recommended dose is 40 mg twice daily. Adverse events include diarrhea, nausea and bloating, and elevations in serum aminotransferase levels, particularly with prolonged therapy and with higher doses. Prolonged therapy can result in deficiencies in fat soluble vitamins, levels of which should be monitored during therapy. Severe adverse events are uncommon but can include gastrointestinal bleeding and bone fractures. Many of these side effects also occur in patients with PBC who are not treated with ileal bile salt transporter inhibitors and the role of linerixibat in causing these symptoms is not always clear.

### Hepatotoxicity

In pre-registration clinical trials in PBC, liver test abnormalities arose in 14% of patients on linerixibat vs 6% on placebo, while serum ALT levels rose to greater than 5 times ULN in 9% vs 3%, but none of these elevations were accompanied by jaundice or significant serum bilirubin levels. The ALT elevations led to dose modification, interruption or therapy or early discontinuation in a proportion of patients. Most patients with PBC and pruritus have serum aminotransferase and alkaline phosphatase elevations in the range of 2 to 5 times ULN, and it can be difficult to distinguish between spontaneous fluctuations in enzyme levels due to the underlying disease vs effects of linerixibat therapy. In most instances, therapy can be continued despite the serum enzyme elevations, at least at a reduced dosage. In clinical trials, serum aminotransferase elevations led to early discontinuation of linerixibat is 3.4% of patients. Alkaline phosphatase and bilirubin levels changed minimally during linerixibat therapy. In addition, during preliminary trials using higher doses of linerixibat, several patients developed drug induced liver injury, that arose within 6 months of starting therapy and improved upon stopping.

Likelihood score: E* (suspected but unproven cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which linerixibat might cause liver injury is not known. It has minimal intestinal absorption and is unlikely to have a direct toxic effect on the liver. The serum aminotransferase elevations that occur with therapy may be due to its effects on absorption of fat-soluble vitamins, nutrients or medications, or to fluxes in the bile acid pool, or to changes in the intestinal microbiome caused by alterations in bile acid concentrations.

### Outcome and Management

While chronic therapy with linerixibat can be associated with mild-to-moderate serum aminotransferase elevations, it has not been linked to cases of clinically apparent liver injury. Because of the frequency of enzyme elevations detected during therapy, the product label for linerixibat recommends obtaining baseline liver tests before initiation of treatment and monitoring them during treatment. Any subsequent rise in ALT or AST values associated with symptoms or jaundice should lead to prompt discontinuation. Patients with persistent elevations above 3 times ULN without symptoms or jaundice should be assessed for other causes of liver injury. If no other cause of the elevations is found, the dose of linerixibat should be reduced or therapy interrupted. There is no known cross sensitivity of the hepatic injury from linerixibat with other agents used to treat pruritus. Because of the similarity in chemical structure and mechanism of action, there may be cross sensitivity to side effects with odevixibat or maralixibat, two other ileal bile acid transporter inhibitors that are FDA-approved, but for different indications.

Drug Class: Ileal Bile Acid Transporter (IBAT) Inhibitors

Other Drugs in the Subclass, Pruritus Agents: Maralixibat, Odevixibat

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Linerixibat– Lynavoy®

DRUG CLASS

Ileal Bile Acid Transporter (IBAT) Inhibitors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Linerixibat)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Linerixibat | 1345982-69-5 | C28-H38-N2-O7-S

## ANNOTATED BIBLIOGRAPHY

References updated: 01-May-2026

Abbreviations: ULN, upper limit of normal; PBC, primary biliary cholangitis.

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 697-8. (Expert review of hepatotoxicity published in 1999 before the availability of inhibitors of the ileal bile acid transporter).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Multi-authored textbook of hepatotoxicity published in 2013, does not discuss linerixibat or other inhibitors of the intestinal bile acid transporter).
Fuchs CD, Halilbasic E, Trauner M. Pathophysiologic basis of alternative therapies for cholestasis. In, Arias IM, Alter HJ, Boyer JL, Cohen DE, Shafritz DA, Thorgeirsson SS, Wolkoff AW. The Liver: biology and pathobiology. 6^th^ ed. Hoboken, NJ: Wiley Blackwell, 2020, pp 364-77. (Textbook of liver physiology and disease).
FDA Medical Review of the New Drug Application for Linerixibat: https://www.accessdata.fda.gov/scripts/cder/daf/index.cfm?event=BasicSearch.process (FDA website with an integrated review of the efficacy and safety of linerixibat).
Tiessen RG, Kennedy CA, Keller BT, Levin N, Acevedo L, Gedulin B, van Vliet AA, et al. Safety, tolerability and pharmacodynamics of apical sodium-dependent bile acid transporter inhibition with volixibat in healthy adults and patients with type 2 diabetes mellitus: a randomised placebo-controlled trial. BMC Gastroenterol. 2018;18:3. (Among 11 patients with type 2 diabetes and 50 healthy volunteers treated with volixibat [n= 46 in dose of 0.5 to 10 mg] or placebo [n=15] daily for 28 days, there were no significant changes in serum glucose or lipid levels between the two groups and while there were “individual” changes from baseline in some laboratory tests, “no clinically relevant changes were seen” ). 29304731
Palmer M, Jennings L, Silberg DG, Bliss C, Martin P. A randomised, double-blind, placebo-controlled phase 1 study of the safety, tolerability and pharmacodynamics of volixibat in overweight and obese but otherwise healthy adults: implications for treatment of non-alcoholic steatohepatitis. BMC Pharmacol Toxicol. 2018;19:10. (Among 84 overweight or obese healthy volunteers treated with volixibat [20 to 80 mg daily] or placebo for 12 days, volixibat therapy was associated with a 4-fold increase in bile acid excretion, a 6-fold increase in serum C4, despite no or barely detectable volixibat in plasma, while side effects occurred in all drug recipients, usually mild to moderate diarrhea starting on day one, but 4 treated patients [and no controls] developed ALT levels above twice ULN, without symptoms or jaundice, and all resolving spontaneously). 29548345
Karpen SJ, Kelly D, Mack C, Stein P. Ileal bile acid transporter inhibition as an anticholestatic therapeutic target in biliary atresia and other cholestatic disorders. Hepatol Int. 2020;14:677-689. (Review of the mechanism of action and rationale for use of ileal bile acid transporter inhibitors as therapy of cholestatic liver diseases in children, such as biliary atresia and Alagille syndrome). 32653991
Levy C, Kendrick S, Bowlus CL, Tanaka A, Jones D, Kremer AE, Mayo MJ, et al.; GLIMMER Study Group. GLIMMER: A randomized phase 2b dose-ranging trial of linerixibat in primary biliary cholangitis patients with pruritus. Clin Gastroenterol Hepatol. 2023;21:1902-1912.e13. (Among 147 patients with PBC treated with one of 5 dose regimens of linerixibat or placebo for 16 weeks, itch scores were improved with the higher doses in comparison to placebo while adverse events were more frequent 31%-78% vs 19%, particularly diarrhea [38-68% vs 11%] and abdominal pain [9-30% vs 8%], and one patient developed moderate liver test abnormalities on linerixibat that resolved within a month of stopping therapy). 36343847
Karatza E, Swift B, Carreño F, Mukherjee S, Casillas L, Lennie J, Fettiplace J, et al. Serum bile acid change correlates with improvement in pruritus in patients with primary biliary cholangitis receiving linerixibat. Liver Int. 2024;44:2293-2302. (Among patients with PBC treated with linerixibat, serum total bile acids decreased in a concentration dependent manner, and the degree of decrease correlated with improvements in pruritus scores; no mention of correlation of bile acid levels with other adverse events such as liver test abnormalities). 38780109
Carreño F, Mehta R, de Souza AR, Collins J, Swift B. Analysis of C4 concentrations to predict impact of patient-reported diarrhea associated with the ileal bile acid transporter inhibitor linerixibat. CPT Pharmacometrics Syst Pharmacol. 2025;14:596-605. (Among 255 persons [86 healthy volunteers and 169 patients with PBC] treated with linerixibat the severity of diarrhea correlated with increases in serum C4 levels, a marker of bile acid synthesis suggesting that increased bile acids reaching the colon was the cause of diarrhea; no mention of correlation with liver test abnormalities during therapy). 39945351
Hirschfield GM, Bowlus CL, Jones DEJ, Kremer AE, Mayo MJ, Tanaka A, Andreone P, et al.; GLISTEN Study Group. Linerixibat in patients with primary biliary cholangitis and cholestatic pruritus (GLISTEN): a randomised, multicentre, double-blind, placebo-controlled, phase 3 trial. Lancet Gastroenterol Hepatol. 2026;11:22-33. (Among 238 adults with PBC and moderate-to-severe pruritus treated with linerixibat or placebo for 24 weeks, pruritus scores decreased more with linerixibat [-2.9 vs -2.2] but adverse events were more common [92% vs 74%], particularly diarrhea [61% vs 18%], abdominal pain [18% vs 3%], and ALT elevations [9% vs 3%] which led to discontinuation in 6% vs 2%, although asymptomatic and not associated with jaundice, and judged to be unrelated to therapy). 41173016

## OTHER REFERENCE LINKS

1. Recent References on Linerixibat: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Linerixibat+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Linerixibat: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Linerixibat)